# Belumosudil

## OVERVIEW

### Introduction

Belumosudil is an orally available small molecule inhibitor of the rho-associated, coiled-coil containing protein kinase that is used to treat refractory chronic graft-versus-host disease. Belumosudil is associated with transient and usually mild elevations in serum aminotransferase levels during therapy but has yet to be linked to cases of clinically apparent acute liver injury.

### Background

Belumosudil (bel" ue moe' soo dil) is an orally available, specific inhibitor the rho-associated, coiled-coil containing protein kinase (ROCK) that is used to treat refractory chronic graft-versus-host disease (GvHD). The inhibition of ROCK1 and ROCK2 downregulates proinflammatory responses and shifts the balance between T17 and Tregs decreasing self antigen-induced immune responses and inhibiting aberrant pro-fibrotic signaling. Belumosudil was shown to have activity in animal models of GvHD. In open label studies in patients with chronic GvHD not responding to standard therapies, belumosudil was shown to induce clinical improvements in 75% of patients. Most of the responses were partial, but often were able to alleviate symptoms and signs adequately to improve quality of life and need for further therapy. Belumosudil was granted accelerated approval in 2021 for adults and children 12 years of age or older with chronic GvHD after failure of at least two systemic therapies. Belumosudil is available in tablets of 200 mg under the brand name Rezurock. The recommended dose is 200 mg orally once daily. Common adverse events include weakness, nausea and vomiting, diarrhea, cough, shortness of breath, edema, bleeding, abdominal pain, musculoskeletal pain, headache, infections, and hypertension. Laboratory abnormalities include decreases in serum phosphate and lymphocytes and increases in gamma glutamyl transferase levels. Potential severe adverse events include embryo-fetal toxicity.

### Hepatotoxicity

In the open label prelicensure clinical trials of belumosudil in patients with refractory chronic GvHD, serum aminotransferase elevations occurred in up to 7% of treated subjects. The elevations were typically mild and transient and values above 5 times the upper limit of normal (ULN) occurred in only 1% to 2% of patients. The elevations occasionally led to early discontinuations, but more often resolved even without dose adjustment. In prelicensure studies, there were no instances of clinically apparent liver injury attributed to belumosudil. Since approval and more widescale availability of belumosudil, there have been no published reports of hepatotoxicity associated with its use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of mild serum enzyme elevations during belumosudil therapy is not known. Serum enzyme elevations are frequent in patients with GvHD, as the immune reactivity often affects the liver. Belumosudil is metabolized in the liver primarily by CYP 3A4 and by a lesser extent by CYP 2C8 and 2D6. Coadministration of belumosudil with strong CYP3A4 inducers or proton pump inhibitors may decrease exposure and require dose increase.

### Outcome and Management

Monitoring of serum aminotransferase levels is recommended for patients starting belumosudil. De novo confirmed elevations in serum aminotransferases levels above 5 times the upper limit of normal should lead to dose modification or temporary cessation. If no other cause of the serum enzyme elevations is identified, or if abnormalities persist or symptoms of liver injury or jaundice arise, belumosudil should be discontinued. There does not appear to be cross reactivity in risk for hepatic injury between belumosudil and other drugs used for chronic GvHD such as tacrolimus, mycophenolate, ibrutinib, or ruxolitinib.

Drug Class: Hematologic Agents; Protein Kinase Inhibitors

Other Drugs for GvHD: Ibrutinib, Ruxolitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Belumosudil – Rezurock®

DRUG CLASS

Protein Kinase Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Belumosudil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Belumosudil | 911417-87-3 | C26-H24-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 July 2024

Abbreviations used: GvHD, graft-vs-host disease; ROCK, rho-associated, coiled-coil containing protein kinase; ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as belumosudil).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not belumosudil).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics; belumosudil is not discussed).
FDA. Multidisciplinary Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214783Orig1s000TOC.cfm (FDA drug approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy mentions that ALT or AST elevations arose in 33% of patients in the safety cohort of 186 patients and were above 5 times ULN in 7% with drug withdrawal because of liver enzyme elevations in only 3 subjects [1.6%], and there were no episodes of clinically apparent liver injury or liver related deaths attributed to therapy).
Blair HA. Belumosudil: first approval. Drugs. 2021;81:1677-1682. (Review of the structure, mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of belumosudil shortly after its approval in the US as therapy of chronic GvHD, mentions adverse events of infection, asthenia nausea, dyspnea, cough, edema, bleeding, muscle ache, headache, abdominal pain, and hypertension; no mention of ALT elevations or hepatotoxicity). 34463931
Jagasia M, Lazaryan A, Bachier CR, Salhotra A, Weisdorf DJ, Zoghi B, Essel J, et al. ROCK2 inhibition with belumosudil (KD025) for the treatment of chronic graft-versus-host disease. J Clin Oncol. 2021;39:1888-1898. (Among 54 patients with GvHD treated with belumosudil [200 mg daily, 200 mg twice daily, or 400 mg daily] the overall response rates were similar in all groups [62% to 69%] and associated with improved quality of life and corticosteroid sparing, while adverse events arose in 98% of patients and were severe in 43%, ALT or AST elevations occurred in 33% that were above 5 times ULN in 7%, but none were associated with jaundice or symptoms or required discontinuation). 33877856
Cutler C, Lee SJ, Arai S, Rotta M, Zoghi B, Lazaryan A, Ramakrishnan A, et al. Belumosudil for chronic graft-versus-host disease after 2 or more prior lines of therapy: the ROCKstar Study. Blood. 2021;138:2278-2289. (Among 132 patients with refractory GvHD treated with belumosudil [200 mg once vs twice daily], the best overall response rates were 74% vs 77% with symptom reduction in 59% vs 62%, while treatment emergent adverse events occurred in 99% which were severe in 38%, but there were no severe hepatic adverse events and ALT elevations arose in 8%, AST 10%, and GGT 12%, and bilirubin in 1%, but there were no instances of clinically apparent liver injury with jaundice). 34265047
Przepiorka D, Le RQ, Ionan A, Li RJ, Wang YH, Gudi R, Mitra S, et al. FDA approval summary: belumosudil for adult and pediatric patients 12 years and older with chronic GvHD after two or more prior lines of systemic therapy. Clin Cancer Res. 2022;28:2488-2492. (Summary and discussion of the FDA analysis of the clinical efficacy and safety of belumosudil as therapy of refractory GvHD that led to its approval, lists side effects that were reported in open label trials which included ALT elevations in 7% of patients and were above 5 times ULN in 2%). 35135839
Lee GH, Guzman AK, Divito SJ, Soiffer RJ, Silk AW, Schmults CD. Cutaneous squamous-cell carcinoma after treatment with ruxolitinib or belumosudil. N Engl J Med. 2023;389:188-190. (Two patients with long term chronic refractory GvHD who were treated with ruxolitinib or belumosudil developed rapidly progressive, invasive squamous cell carcinomas). 37437151
Malard F, Mohty M. Updates in chronic graft-versus-host disease management. Am J Hematol. 2023;98:1637-1644. (Review of the clinical features, pathogenesis, diagnosis, and therapy of chronic GvHD, first line treatment being corticosteroids which are typically required long term and require second line therapy in approximately half of patients, most agents being used off label [such as calcineurin and mTOR inhibitors], while more recently 3 unique kinase inhibitors with immunomodulatory actions have been approved specifically for refractory GvHD: ibrutinib [2017], ruxolitinib [2021), and belumosudil [2021]; no discussion of hepatotoxicity). 37483142
Inamoto Y, Kato K, Kawakita T, Onishi Y, Matsuoka KI, Shiratori S, Ikegame K, et al. Hiramoto N, et al. An open-label study of belumosudil, a selective ROCK2 inhibitor, as second or subsequent line of therapy for steroid-dependent/steroid-resistant chronic GVHD. Am J Hematol. 2024 Jun 27. Epub ahead of print. (Among 21 Japanese patients with refractory GvHD treated with belumosudil for an average of 9.2 months, 87% had a treatment emergent adverse event, most frequently diarrhea, but none resulted in drug discontinuation or death, 2 patients developed herpes zoster; no mention of ALT elevations or hepatotoxicity). 38934629

## OTHER REFERENCE LINKS

1. Recent References on Belumosudil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Belumosudil+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Belumosudil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Belumosudil)